# Levetiracetam

## OVERVIEW

### Introduction

Levetiracetam is a relatively unique anticonvulsant that is typically used in combination with other antiepileptic medications for partial onset seizures. Levetiracetam has been linked to rare instances of serum aminotransferase and alkaline phosphatase elevations during treatment and to rare cases of clinically apparent drug induced liver disease.

### Background

Levetiracetam (lee" ve tre ra' se tam) is a pyrrolidine derivative unrelated in structure to other anticonvulsant medications. Its mechanism of action is not known, but it is believed to act by preventing secondary spread of focal seizure activity and to decrease simultaneous neuronal firing. Levetiracetam was approved for use in epilepsy in 1999 and current indications are as adjunctive therapy for partial onset seizures, generalized tonic-clonic seizures and myoclonic seizures in both children and adults. Levetiracetam is available as tablets of 250, 500, 750 and 1000 mg generically and under the brand name Keppra. Extended release tablets, liquid oral formulations and injectable solutions are also available. The recommended initial dose in adults is 500 mg twice daily with dose escalation based upon tolerance and effect to a maximum of 1500 mg twice daily or 3000 mg of extented release formulations once daily. Dosing in children is based upon body weight. Common side effects include dizziness, somnolence, weakness, fatigue, irritability and headache. Rare but potentially serious adverse events include hypersensitivity reactions, rash and cognitive effects including suicidal ideation and behavior.

### Hepatotoxicity

Prospective studies reported that chronic levetiracetam therapy was not accompanied by significant elevations in serum aminotransferase levels and clinically apparent liver injury was not observed. Since its approval for use and wide spread availability, however, levetiracetam has been linked to rare instances of serum enzyme elevations and occasional cases of clinically apparent liver injury. The time to onset of liver injury after starting levetiracetam has ranged from 1 week to 5 months and the usual pattern of injury has been hepatocellular. Immunoallergic features and autoantibodies were rare. At least one case of acute liver failure attributed to levetiracetam has been published, but the number of reported cases clinically apparent cases of liver injury has been few. In addition, levetiracetam is usually considered a reasonable alternative therapy in patients who develop anticonvulsant hypersensitivity (DRESS) syndrome after aromatic anticonvulsant use despite the fact that it has been implicated in rare instances of DRESS and Stevens Johnson syndrome.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of levetiracetam hepatotoxicity is unknown, but is likely to be hypersensitivity. Levetiracetam has minimal hepatic metabolism and does not affect CYP 450 isoenzyme activity.

### Outcome and Management

A single case of acute liver failure attributed to levetiracetam has been published. The liver injury recurred rapidly with reexposure. Chronic injury from levetiracetam therapy has not been reported. There is no evidence for cross sensitivity to hepatic injury between levetiracetam and other anticonvulsants.

Drug Class: Anticonvulsants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Levetiracetam – Generic, Keppra®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Levetiracetam | 102767-28-2 | C8-H14-N2-O2 | Levetiraceta chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 18 April 2019

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999; levetiracetam is not discussed).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-41. (Review of anticonvulsant induced liver injury published in 2013; levetiracetam is not mentioned).
Smith MD, Metcalf CS, Wilcox KS. Pharmacotherapy of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
Knowles SR, Shapiro LE, Shear NH. Anticonvulsant hypersensitivity syndrome: incidence, prevention and management. Drug Saf 1999; 21: 489-501. (Review of anticonvulsant hypersensitivity syndrome: triad of fever, rash and internal organ injury occurring 1-8 weeks after exposure to anticonvulsant; liver being most common internal organ involved. Occurs in 1:1000-1:10,000 initial exposures to phenytoin, carbamazepine, phenobarbital or lamotrigine, unrelated to dose, perhaps predisposed by valproate; liver injury arises 1-4 weeks after onset of rash and ranges in severity from asymptomatic ALT elevations to icteric hepatitis to acute liver failure. High mortality rate with jaundice; other organs involved include muscle, kidney, brain, heart and lung. Pseudolymphoma syndrome and serum sickness like syndrome are separate complications of anticonvulsants. Role of corticosteroids is uncertain; cross reactivity among the agents should be assumed). 10612272
Hamer HM, Morris HH. Hypersensitivity syndrome to antiepileptic drugs: a review including new anticonvulsants. Clevel Clin J Med 1999; 66: 239-45. (Clinical review of anticonvulsant hypersensitivity syndrome: occurs in 1-5/10,000 users, higher risk in African Americans and affected siblings; liver involvement common, but most cases anicteric; other manifestations include facial edema, lymphadenopathy, bone marrow aplasia, pseudolymphoma, thyroiditis, interstitial nephritis, switching to valproate and benzodiazepines is safe, levetiracetam is also an option). 10199060
Betts T, Waegemans T, Crawford P. A multicentre, double-blind, randomized, parallel group study to evaluate the tolerability and efficacy of two oral doses of levetiracetam, 2000 mg daily and 4000 mg daily, without titration in patients with refractory epilepsy. Seizure 2000; 9: 80-7. (Comparison of levetiracetam–2000 or 4000 mg daily–compared to placebo as add-on treatment for 24 weeks in 119 patients with refractory seizures; “there were no significant changes in clinical laboratory parameters…” and no specific mention of ALT levels). 10845730
Nash EM, Sangha KS. Levetiracetam. Am J Health Syst Pharm 2000; 58: 1195-9. (Review of pharmacology and efficacy of levetiracetam, a new anticonvulsant that received rapid approval and is used as adjunctive therapy only; no hepatic metabolism; no mention of hepatic side effects or ALT elevations during therapy). 11449876
Jain KK. An assessment of levetiracetam as an anti-epileptic drug. Exp Opin Invest Drugs 2000; 9: 1611-24. (Review of levetiracetam use in both partial epilepsy and generalized seizures; no mention of hepatic side effects). 11060765
Partap S, Fisher PG. Levetiracetam for seizures in children with brain tumors and other cancers. Pediatr Blood Cancer 2009; 52: 288-9. (Extensive review of chemistry, pharmacology, metabolism and pharmacokinetics of levetiracetam; it does not undergo hepatic metabolism, no interaction with CYP 450 isoenzymes and no significant drug-drug interactions). 18831033
Abou-Khalil B. Levetiracetam in the treatment of epilepsy. Neuropsychiatr Dis Treat 2008; 4: 507-23. (Review on use of levetiracetam in epilepsy; serious adverse events are rare; allergic rash in <1%; no mention of hepatic toxicity or ALT elevations). 18830435
Tan TC, de Boer BW, Mitchell A, Delriviere L, Adams LA, Jeffrey GP, Macquillan G. Levetiracetam as a possible cause of fulminant liver failure. Neurology 2008; 71: 685-6. (Patient developed acute liver failure 1 month after being switched from oxcarbazepine to levetiracetam [bilirubin 34.6 mg/dL, ALT 1610 U/L, Alk P 246 U/L], which recurred on restarting levetiracetam post liver transplant [bilirubin rising to 4.5 mg/dL, ALT 350 U/L, Alk P 650 U/L], resolving within 2 weeks of stopping). 18725594
Skopp G, Schmitt HP, Pedal I. [Fulminant liver failure in a patient on carbamazepine and levetiracetam treatment associated with status epilepticus]. Arch Kriminol 2006; 217: 161-75. German. (Patient on long term carbamazepine and levetiracetam developed acute liver failure after a period of status epilepticus and mild but prolonged hypotension; autopsy was more compatible with ischemic hepatitis than drug induced liver injury and no routine liver tests [bilirubin, ALT, Alk P, LDH, CPK, protime] provided). 16910300
Briggs DE, French JA. Levetiracetam safety profiles and tolerability in epilepsy patients. Expert Opin Drug Saf 2004; 3: 415-24. (Analysis of safety in phase II and III prelicensure trials of levetiracetam; adverse events in 15%, most commonly somnolence, asthenia, headache and infection, little change in weight and no reports of hepatotoxicity or ALT elevations). 15335297
Patsalos PN. Clinical pharmacokinetics of levetiracetam. Clin Pharmacokinet 2004; 43: 707-24. (Review of chemical properties, pharmacokinetics, and pharmacology of levetiracetam which is a pyrrolidone derivative, structurally unrelated to other anticonvulsants, rapid absorption and little hepatic metabolism or effects of CYP isoenzymes). 15301575
LaRoche SM. A new look at the second-generation antiepileptic drugs: a decade of experience. Neurologist 2007; 13: 133-9. (Review of second generation anticonvulsants approved since 1994 including felbamate, gabapentin, lamotrigine, topiramate, tiagabine, levetiracetam, oxcarbazepine, zonisamide and pregabalin; no mention of liver toxicity from levetiracetam). 17495757
Björnsson E. Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scan 2008; 118: 281-90. (Review of all anticonvulsants; suggests that clinically significant hepatotoxicity has not been reported with levetiracetam). 18341684
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, no case was attributed to levetiracetam). 18955056
Gallerani M, Mari E, Boari B, Carletti R, Marra A, Cavallo M. Pancytopenia associated with levetiracetam treatment. Clin Drug Investig 2009; 29: 747-51. (65 year old woman developed pancytopenia 9 days after starting levetiracetam followed by pneumonia, gallstone obstruction and multiple liver abscesses [bilirubin 5.4 mg/dL, ALT 127 U/L, Alk P 1169 U/L], ultimately resolving after antibiotic therapy and stopping levetiracetam). 19813778
Broli M, Provini F, Naldi I, Bisulli F, Sama C, Baruzzi A, Tinuper P, Riva R. Unexpected gamma glutamyltransferase rise increase during levetiracetam monotherapy. Epileptic Disord 2010; 12: 81-2. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/20159672) (58 year old woman developed persistent mild and asymptomatic elevations in GGT [initially 29 rising to 157 U/L, ALT normal] 4 months after being switched from valproate to levetiracetam, and resolving within 2 months of switching to lamotrigine).
Müller CA, Schäfer M, Schneider S, Heimann HM, Hinzpeter A, Volkmar K, Förg A, et al. Efficacy and safety of levetiracetam for outpatient alcohol detoxification. Pharmacopsychiatry 2010; 43: 184-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/20503149) (Controlled trial of 7 days of levetiracetam versus placebo in 131 patients with alcohol dependence during withdrawal; “There were 3 cases of worsening of pre-existing liver parameter elevations”, but no details given).
Richter C, Hinzpeter A, Schmidt F, Kienast T, Preuss UW, Plenge T, Heinz A, et al. Levetiracetam for the treatment of alcohol withdrawal syndrome: a multicenter, prospective, randomized, placebo-controlled trial. J Clin Psychopharmacol 2010; 30: 720-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/21105289) (Controlled trial of 7 days of levetiracetam versus placebo in 106 patients with alcohol dependence during withdrawal found no difference in withdrawal symptoms and no “negative influence on laboratory parameters including liver enzymes”).
Xiong N, Hou L, Lu N, Mohamed AA, Wang T, Huang Y. Probable levetiracetam-related serum alkaline phosphatase elevation. BMC Neurol 2012; 12: 97. (One year old Chinese girl with brain injury was found to have rising levels of Alk P 5 months after starting levetiracetam [Alk P 162 rising to 1613 and then 4557 U/L with normal levels of bilirubin, ALT and GGT], resolving within 6 months of stopping). 22994584
Gómez-Zorrilla S, Ferraz AV, Pedrós C, Lemus M, Peña C. Levetiracetam-induced drug reaction with eosinophilia and systemic symptoms syndrome. Ann Pharmacother 2012; 46: e20. (31 year old man with brain tumor developed fever, rash and interstitial pneumonitis 49 days after starting levetiracetam, improving with dexamethasone therapy, but recurring [ALT 60 U/L] and resolving only after stopping levetiracetam and switching to phenytoin). 22764327
Sethi NK, Sethi PK, Torgovnick J, Arsura E, Cukierwar F. Asymptomatic elevation of liver enzymes due to levetiracetam: a case report. Drug Metabol Drug Interact 2013; 28: 123-4. (62 year old woman was found to have serum enzyme elevations without symptoms 10 days after starting levetiracetam therapy [bilirubin not given, ALT 289 U/L, Alk P 567 U/L], which fell to near normal levels within a week of stopping and did not rise with subsequent topiramate therapy). 23420283
Drugs for epilepsy. Treat Guidel Med Lett 2013; 11: 9-18. (Concise review of the efficacy and safety of drugs used to treat epilepsy; levetiracetam can cause Stevens Johnson syndrome and toxic epidermal necrolysis, but liver adverse events were not mentioned). 23348233
Gutiérrez-Grobe Y, Bahena-Gonzalez JA, Herrera-Gomar M, Mendoza-Diaz P, García-López S, González-Chon O. Acute liver failure associated with levetiracetam and lacosamide combination treatment for unspecified epileptic disorder. Case Rep Emerg Med 2013; 2013: 634174. (22 year old woman with status epilepticus 2 months after starting lacosamide and levetiracetam had markedly abnormal serum enzymes [bilirubin 2.1 mg/dL, ALT 4341 U/L, Alk P 74 U/L, CPK 2989 U/L, myoglobin in serum], falling to normal within 12 days of stopping both drugs). 24027645
Azar NJ, Aune P. Acute pancreatitis and elevated liver transaminases after rapid titration of oral levetiracetam. J Clin Neurosci 2014; 21: 1054-4. (25 year old woman developed fever, abdominal pain and fatigue within a week of starting levetiracetam [bilirubin 2.7 mg/dL, ALT 1083 U/L, Alk P 250 U/L, amylase 439 U/L], resolving within 7 days of stopping and not recurring with pregabalin). 24291473
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 7 [4%] of which were attributed to anticonvulsants but none to levetiracetam). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were due to anticonvulsants but none were attributed to levetiracetam). 25754159
İşgüder R, Güzel O, Ceylan G, Yılmaz Ü, Ağın H. A comparison of intravenous levetiracetam and valproate for the treatment of refractory status epilepticus in children. J Child Neurol 2016; 31: 1120-6. (Among 78 children with status epilepticus admitted to a Turkish pediatric ICU between 2011 and 2014, liver test abnormalities arose in 4 of 32 receiving intravenous [iv] valproate [peak ALT 4 times ULN] vs none of 46 given iv levetiracetam). 27080042
Selvaraj V, Madabushi JS, Gunasekar P, Singh SP. Levetiracetam associated acute hepatic failure requiring liver transplantation: case report. J Neurol 2016; 263: 814-5. (50 year old man with epilepsy developed elevated liver tests 8 weeks after starting levetiracetam and olanzapine [bilirubin <1.0 rising to 20.4 mg/dL, ALT 1456 rising to 4300 IU, INR 11], with progressive worsening requiring emergency liver transplantation). 26902232
Rachamallu V, Song MM, Reed JM, Aligeti M. Levetiracetam-induced transaminitis in a young male with traumatic brain injury. Oxf Med Case Reports 2017; 2017 (11): (18 year old man with traumatic brain injury developed persistent ALT elevations after starting levetiracetam [61 rising to 311 U/L, no mention of bilirubin or Alk P], which fell to near normal when it was stopped). 29744119
Khoury T, Chen S, Abu Rmeileh A, Daher S, Yaari S, Benson AA, Cohen J, Mizrahi M. Acute liver injury induced by levetiracetam and temozolomide co-treatment. Dig Liver Dis 2017; 49: 297-300. (A retrospective analysis of 94 patients with brain cancer treated with temozolomide with or without levetireacetam found that liver test abnormalities were more frequent with combination therapy [ALT elevations in 73% vs 10%, Alk P 19% vs 7%, bilirubin in 27% vs 1.5%] and one patient on the combination died of acute liver failure). 28034663
Bunchorntavakul C, Reddy KR. Drug hepatotoxicity: newer agents. Clin Liver Dis 2017; 21: 115-34. (Review of recently approved drugs that have been associated with liver injury mentions that levetiracetam has little hepatic metabolism but has been associated with transient serum ALT elevations and at least one case of acute liver failure [Tan 2008]). 27842767
Vidaurre J, Gedela S, Yarosz S. Antiepileptic drugs and liver disease. Pediatr Neurol 2017; 77: 23-36. (Review of the use of anticonvulsants in patients with liver disease recommends use of agents that have little hepatic metabolism such as levetiracetam, lacosamide, topiramate, gabapentin and pregabalin, levetiracetam being an "ideal" first line therapy for patients with liver disease because of its safety and lack of pharmacokinetic interactions).29097018
Drugs for epilepsy. Med Lett Drugs Ther 2017; 59 (1526): 121-30. (Concise review of the drugs available for therapy of epilepsy lists levetiracetam as a drug of choice for partial and generalized seizures as well as for atypical absence, myoclonic and atonic seizures and mentions Stevens Johnson syndrome as a rare adverse event but does not mention ALT elevations or liver injury due to levetiracetam). 28746301
Comparison table: some oral antiepileptic drugs. Med Lett Drugs Ther 2017; 59 (1521): e130-e136. (Table of oral antiepileptic drugs with listing of oral formulations, usual maintenance dosages, adverse effects, drug interactions, indications and costs; does not mention adverse events of liver injury or ALT elevations for levetiracetam). 28746302
Attilakos A, Dinopoulos A, Paschalidou M, Tsirouda M, Prasouli A, Siafakas N, Garoufi A. Effect of levetiracetam monotherapy on liver enzymes and creatine kinase concentrations in children with epilepsy: a prospective study. J Clin Neurol 2018; 14: 594-595. (Among 26 Korean children with new onset epilepsy started on levetiracetam monotherapy and monitored prospectively for liver test abnormalities, there were minor rises in serum Alk P and GGT but none in ALT, AST or CPK). 30284772
Jayashankar S, Munakomi S, Sayeerajan V, Kafle P, Chaudhary P, Thingujam J, Poudel D, et al. Case report: levetiracetam causing acute liver failure complicating post-operative management in a neurosurgical patient. F1000Res 2019; 8: 187. (55 year old man developed jaundice 3 days after emergency craniotomy for an intra-cerebellar bleed while on levetiracetam [bilirubin 9.4 mg/dL, ALT 926 U/L, Alk P 298 U/L, INR 1.09], resolving within 5 days of stopping). 30984385
Haznedar P, Doğan Ö, Albayrak P, Öz Tunçer G, Teber S, Deda G, Eminoglu FT. Effects of levetiracetam and valproic acid treatment on liver function tests, plasma free carnitine and lipid peroxidation in childhood epilepsies. Epilepsy Res 2019; 153: 7-13. (In a cross-sectional analysis of 51 children with epilepsy treated with valproate or levetiracetam, serum ALT, AST and GGT levels were in the normal range in all and did not differ from a group of healthy controls). 30925397
Han XD, Koh MJ, Wong SMY. Drug reaction with eosinophilia and systemic symptoms in a cohort of Asian children. Pediatr Dermatol 2019 Mar 28. [Epub ahead of print] (Among 10 children with DRESS syndrome seen at a single, Singapore referral center between 2006 and 2016, 3 cases were attributed to SMZ/TMP, 2 to carbamazepine, 1 sulfasalazine, 2 phenobarbital and 1 to levetiracetam [latency 28 days]; all had ALT elevations [88 to 1172 U/L], bilirubin was elevated in 7, but none had acute liver failure and none were fatal). 30920020

## OTHER REFERENCE LINKS

1. Recent References on Levetiracetam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(levetriacetam+AND+piracetam/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Levetiracetam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=levetriacetam)